# Cyclobenzaprine

## OVERVIEW

### Introduction

Cyclobenzaprine is a centrally acting muscle relaxant closely related to the tricyclic antidepressants. Despite its similarity to tricyclic antidepressants, there is little evidence that cyclobenzaprine causes liver injury.

### Background

Cyclobenzaprine (sye" kloe ben' za preen) is a tricyclic antidepressant derivative that relaxes skeletal muscle by an unknown mechanism of action. Cyclobenzaprine is also a central nervous system depressant, and its efficacy may be related to its sedative effects. Cyclobenzaprine is used for the treatment of painful muscle spasms from acute muscle conditions. The recommended dosage in adults is 5 to 10 mg three times daily for 3 to 4 weeks. Cyclobenzaprine is available in tablets of 5 and 10 mg in multiple generic forms and under the trade names of Flexeril, Flexamid and Amrix. Extended release capsules of 15 and 30 mg are also available. Cyclobenzaprine was approved for use in the United States in 1977 and it remains widely used with more than 10 million prescriptions filled yearly. It is usually administered for limited periods of time. Common side effects include sleepiness, dry mouth, dizziness and headache.

### Hepatotoxicity

The product insert for cyclobenzaprine mentions that abnormal liver function, hepatitis, jaundice, and cholestasis occur in <1% of patients. Details about these cases are not available and no convincing case reports of cyclobenzaprine hepatotoxicity have been published.

Likelihood score: E* (Unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Because cyclobenzaprine is a tricyclic antidepressant derivative, it is unclear why it is not associated with hepatotoxicity similar to that attributed to the tricyclic antidepressants. Cyclobenzaprine is metabolized by the liver and has an enterohepatic circulation and half-life of several days.

### Outcome and Management

The minor ALT elevations associated with chronic cyclobenzaprine use are usually asymptomatic and transient. Any elevation of greater than 10 times the upper limit of normal or persistence of abnormalities greater than 5 times the upper limit of normal should lead to discontinuation. Rechallenge is not recommended unless the agent is felt to be highly needed. There is no reason to suspect cross sensitivity to hepatic injury among the various muscle relaxant drugs.

Drug Class: Muscle Relaxants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cyclobenzaprine – Generic, Flexeril®

DRUG CLASS

Autonomic Agents: Muscle Relaxants, Central

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=cyclobenzaprine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Cyclobenzaprine | 303-53-7 | C20-H21-N | Cyclobenzaprine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2017

Zimmerman HJ. Muscle spasmolytics. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 544-45. (Expert review of hepatotoxicity published in 1999 discusses dantrolene, chlorzoxazone and baclofen but does not mention cyclobenzapine).
Hibbs RE, Zambon AC. Agents acting at the neuromuscular junction and autonomic ganglia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 255-76. (Textbook of pharmacology and therapeutics).
Katz WA, Dube J. Cyclobenzaprine in the treatment of acute muscle spasm: review of a decade of clinical experience. Clin Ther 1988; 10: 216-28. (Thorough review of pre- and postmarketing studies of efficacy and safety of cyclobenzaprine; "Routine laboratory measurements...obtained at the start and end of each study showed no alterations indicative of organ toxicity"). 3078905
Winchell GA, King JD, Chavez-Eng CM, Constanzer ML, Korn SH. Cyclobenzaprine pharmacokinetics, including the effects of age, gender, and hepatic insufficiency. J Clin Pharmacol 2002; 42: 61-9. (Four studies from sponsor showing linear pharmacokinetics, slight accumulation, greater accumulation in liver disease, but no serious adverse events or liver toxicity). 11808825
Spiller HA, Cutino L. Fatal cyclobenzaprine overdose with postmortem values. J Forensic Sci 2003; 48: 883-4. (Two patients with intentional cyclobenzaprine overdose died of respiratory arrest; one had chronic hepatitis C). 12877312
Chou R, Peterson K, Helfand M. Comparative efficacy and safety of skeletal muscle relaxants for spasticity and musculoskeletal conditions: a systematic review. J Pain Symptom Manage 2004; 28: 140-75. (Thorough review of the pharmacology, efficacy and side effects of the muscle relaxants). 15276195
Toth PP, Urtis J. Commonly used muscle relaxant therapies for acute low back pain: a review of carisoprodol, cyclobenzaprine hydrochloride, and metaxalone. Clin Ther 2004; 26: 1355-67. (A review of safety and efficacy of muscle relaxants including cyclobenzaprine states that its common side effects include somnolence, dry mouth, fatigue, and headache; no mention of liver injury or ALT elevations). 15530999
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a specific muscle relaxant). 15390328
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.7%] were attributed to muscle relaxants, but none specifically to cyclobenzaprine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cyclobenzaprine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cyclobenzaprine/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/12/01/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cyclobenzaprine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cyclobenzaprine)